# Enalapril

## OVERVIEW

### Introduction

Enalapril is an angiotensin-converting enzyme (ACE) inhibitor widely used in the therapy of hypertension and heart failure. Enalapril is associated with a low rate of transient serum aminotransferase elevations and has been linked to rare instances of acute liver injury.

### Background

Enalapril (en al' a pril) was the second ACE inhibitor to be approved for use in the United States and is still widely used for therapy of hypertension and heart failure. Like other ACE inhibitors, enalapril inhibits the conversion of angiotensin I, a relatively inactive molecule, to angiotensin II which is the major mediator of vasoconstriction and volume expansion induced by the renin-angiotensin system. Other enzymes besides that which converts angiotensin I to II may also be inhibited, which may account for some of the side effects of the ACE inhibitors. Like many other ACE inhibitors, enalapril is a prodrug and must be hydrolyzed in the liver to its active carboxylic metabolite, enalaprilat. Enalapril was approved for use in the United States in 1985 and current indications include hypertension, symptomatic heart failure and prevention of progression of left ventricular dysfunction. Enalapril is available in 2.5, 5, 10 and 20 mg tablets in generic forms and under the trade name Vasotec. The typical initial oral dose of enalapril in adults is 2.5 to 5 mg once or twice daily, which can be increased to a maximum of 40 mg daily. Injectable formulations of enalaprilat, the active metabolic product of enalapril, are available in 1 and 2 mL vials of 1.25 mg/mL for intravenous administration. Enalapril is also available in fixed combinations with hydrochlorothiazide (generically and as Vaseretic) and with felodipine (Lexxel). Common side effects include dizziness, fatigue, headache, cough, gastrointestinal upset and skin rash. Rare, but potentially serious adverse events include hypersensitivity reactions, anaphylaxis and fetal or neonatal mortality.

### Hepatotoxicity

Enalapril, like other ACE inhibitors, has been associated with a low rate of serum aminotransferase elevations (<2%) that, in controlled trials, was no higher than with placebo therapy. These elevations were transient and rarely required dose modification. In addition, more than a dozen instances of clinically apparent acute liver injury have been reported with enalapril therapy. The onset is usually within 2 to 12 weeks of starting therapy and the serum enzyme pattern is typically cholestatic. In some instances, cholestasis has been prolonged and relapsing and associated with persistent elevations in serum alkaline phosphatase, suggestive of vanishing bile duct syndrome. Immunoallergic manifestations (rash, fever, eosinophilia) are infrequent and most patients do not develop autoantibodies. There have also been striking instances of enalapril liver injury with a hepatocellular pattern. These cases typically have a long latency (one or more years), some of which have been severe and fatal. The appearance of an acute liver injury more than a year after starting a medication is distinctly unusual, but has been described for several ACE inhibitors.

Likelihood score: B (likely but rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the minor serum aminotransferase elevations associated with enalapril is not known. The clinically apparent cases of hepatotoxicity due to enalapril are clearly idiosyncratic and likely due to a reaction to a metabolite. The instances of enalapril associated liver injury associated with a long latency may be due to a different mechanism. Enalapril is metabolized by the liver to enalaprilat, its active form, but further hepatic metabolism is minimal and enalapril has little interaction with the cytochrome P450 system.

### Outcome and Management

Most instances of acute liver injury reported with enalapril use have been self limited, but severe and fatal instances have been reported as have cases of vanishing bile duct syndrome. Patients with severe enalapril induced acute liver injury should avoid use of other ACE inhibitors, although cross sensitivity to liver injury among the members of this class of agents has not always been shown.

References to the safety and potential hepatotoxicity of enalapril are given in the Overview section on the Angiotensin-Converting Enzyme (ACE) Inhibitors (Updated February 2018).

Drug Class: Antihypertensive Agents, Angiotensin-Converting Enzyme Inhibitors

## CASE REPORTS

### Case 1. Cholestatic hepatitis due to enalapril.

[Modified from: Todd P, Levison D, Farthing MJ. Enalapril-related cholestatic jaundice. J R Soc Med 1990; 83: 271-2. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/2342045)]

A 67 year old woman was switched from atenolol to enalapril (15 mg daily) in combination with a diuretic (cyclopenthiazide 250 mcg daily) for better control of her essential hypertension. Six weeks later she developed dark urine, jaundice and pruritus. She had no history of liver disease, did not abuse alcohol and had no risk factors for acquiring viral hepatitis. On examination, she was jaundiced but had no fever, rash or peripheral manifestations of chronic liver disease. Laboratory testing showed a total serum bilirubin of 8.9 mg/dL, with moderate elevations of aminotransferase (AST 236 U/L) and alkaline phosphatase levels (437 U/L) (Table). There was no eosinophilia and the prothrombin time was normal. Tests for hepatitis A and B were negative as were autoantibodies. Abdominal ultrasound showed no evidence of biliary obstruction. A liver biopsy showed intrahepatic cholestasis typical of drug induced liver injury. Four days after admission, enalapril was stopped and she began to improve rapidly. When seen 3 months later, she was asymptomatic and laboratory values were normal.

#### Key Points

Medication: | Enalapril (15 mg daily)
Pattern: | Cholestatic (R=1.4)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 6 weeks to jaundice
Recovery: | Partial after 2 weeks, complete after 12 weeks
Other medications: | Cyclopenthiazide

#### Laboratory Values

Time After Starting | Days After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
6 weeks | 0 | 236 | 437 | 8.9 | Admission for jaundice
6.5 weeks | 0 | 110 | 505 | 6.4 | Enalapril stopped
7 weeks | 3 days | 65 | 490 | 3.8
8 weeks | 10 days | 25 | 205 | 0.9 | Hospital discharge
5 months | 3 months | 20 | 75 | 0.6
Normal Values | | <40 | <100 | <1.2

* Values and dates in Table estimated from Figure 1.

#### Comment

The patient developed a cholestatic hepatitis within 6 weeks of starting enalapril therapy and recovery was prompt once the medication was stopped. This is a typical history for enalapril induced acute liver injury. In rare instances of ACE inhibitor associated cholestatic hepatitis, jaundice and pruritus can be prolonged and progress to vanishing bile duct syndrome leading to cirrhosis and end stage liver disease. However, slow but eventually complete recovery is the more common outcome.

### Case 2. Cholestatic hepatitis arising after 18 months of enalapril therapy.

[Modified from a case in the database of the Drug-Induced Liver Injury Network]

An 83 year old man with hypertension and coronary artery disease had been taking enalapril and metoprolol for 18 months when he developed fatigue, anorexia, pruritus and jaundice. He had a history of jaundice in his teens which resolved completely. He had also been a moderately heavy drinker much of his life, but quit drinking alcohol 20 years previously. He had no history of drug hypersensitivity or reactions. His other medical problems included hypothyroidism for which he had taken levothyroxine for 7 years, hypercholesterolemia for which he had taken simvastatin for 7 years and fenofibrate for 6 months. On examination, he was jaundiced but had no fever or peripheral manifestations of chronic liver disease. Laboratory tests showed a bilirubin of 5.8 mg/dL, ALT 70 U/L and alkaline phosphatase of 369 U/L; these tests had been repeatedly normal during the previous six months. Tests for hepatitis A, B and C were negative. He had low levels of antinuclear antibody (1:80) and a slight elevation in serum immunoglobulin G (1,734 mg/dL: normal <1,700 mg/dL). Magnetic resonance cholangiopancreatography showed no evidence of gallstones or biliary obstruction. A liver biopsy showed intrahepatic cholestasis suggestive of drug induced liver injury. Simvastatin was stopped and his enalapril, metoprolol and fenofibrate were continued. His serum bilirubin and alkaline phosphatase remained elevated. Three months after onset of jaundice, enalapril was stopped and he rapidly improved, his pruritus resolving and bilirubin falling to normal within two weeks. Serum alkaline phosphatase improved more slowly and was still mildly elevated 6 months later.

#### Key Points

Medication: | Enalapril (dose not provided)
Pattern: | Cholestatic (R=0.6)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 16 months
Recovery: | Partial after 2 weeks
Other medications: | Simvastatin, fenofibrate, metoprolol, synthroid

#### Laboratory Values

Time After Starting | Weeks After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | Pre | 25 | 104 | 0.5 | Enalapril started
12 months | | 24 | 82 | 0.5 | Fenofibrate started
14 months | | 15 | 114 | 0.4
16 months | | 27 | 94 | 0.4
18 months | Pre | 70 | 369 | 5.8 | Simvastatin stopped
19 months | | 51 | 425 | 8.7
20 months | | 97 | 272 | 4.7
21 months | 0 | 91 | 578 | 7.7 | Enalapril stopped
| 3 days | 48 | 511 | 0.9
| 10 days | 40 | 423 | 0.7 | Fenofibrate stopped
| 2 weeks | 55 | 356 | 0.6
| 3 weeks | 44 | 314 | 0.6
22 months | 5 weeks | 71 | 285 | 0.7
| 6 weeks | 42 | 211 | 0.7
23 months | 8 weeks | 52 | 228 | 0.5
Normal Values | | <40 | <100 | <1.2

#### Comment

The patient developed a cholestatic hepatitis which was initially attributed to simvastatin. When he had not improved three months later, enalapril was stopped, and jaundice and pruritus improved within a few weeks. Serum ALT and alkaline phosphatase levels remained mildly elevated. Stopping fenofibrate appeared to have no effect. Eight months after stopping enalapril, the patient had no symptoms of liver disease but had mildly elevated serum enzymes, these tests having been repeatedly normal in the past. Had all medications been discontinued when he first developed jaundice, the role of enalapril versus simvastatin (or fenofibrate) would have been difficult to define. The long latency period (18 months) to onset of clinically apparent liver injury is uncommon, but has been described both for the ACE inhibitors such as enalapril and the statins such as simvastatin. The long latency associated cases of hepatotoxicity due to ACE inhibitors is typically, but not invariably, hepatocellular.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Enalapril – Generic, Vasotec®

DRUG CLASS

Angiotensin-Converting Enzyme Inhibitors

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Enalapril)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Enalapril | 75847-73-3 | C20-H28-N2-O5 | Enalapril Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Enalapril: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Enalapril/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Enalapril: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Enalapril)